# Drotrecogin alfa

## OVERVIEW

### Introduction

Drotrecogin alfa is a recombinant form of activated human protein C which was previously used to treat patients with severe sepsis and organ failure. Drotrecogin alfa was typically given to critically ill patients in whom severe adverse events were common, but it was never linked to an increase in significant serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Drotrecogin (droe" tre koe' jin) alfa is a recombinant form of activated human protein C, which is believed to intervene in multiple sites in the systemic response to infection and to be deficient in some patients with severe septicemia. Protein C is a serine protease that has antithrombotic, antiinflammatory and profibrinolytic properties which may play a role in limiting the injurious effects of the severe systemic response to septicemia. Administration of drotrecogin alfa in patients with severe sepsis and organ failure was initially reported to improve outcomes, decreasing 28 day mortality. However, subsequent large, randomized controlled trials found no evidence for its efficacy in severe sepsis. Drotrecogin alfa was approved in the United States for use in severe sepsis with acute organ failure and high risk of death in 2001. After postmarketing studies demonstrated that it had little or no effect on mortality, it was withdrawn by the sponsor in 2011. Drotrecogin alfa was previously available in single use vials of 5 and 20 mg under the brand name Xigris. The recommended dose was 24 µg/kg per hour for 96 hours. Side effects were difficult to attribute to the therapy because the drug was used only in critically ill patients, in whom severe adverse events were common and expected. Adverse events thought to be due to the drotrecogin alfa infusions included bleeding which could be severe, but was rarely fatal.

### Hepatotoxicity

In preregistration studies of drotrecogin alfa, no mention was made of serum enzyme elevations or episodes of clinically apparent liver injury. However, patients treated were critically ill and sepsis on its own commonly causes serum enzyme elevations and jaundice. After approval and more widespread use of drotrecogin alfa, there were no published reports of hepatotoxicity associated with its use. The withdrawal of drotrecogin alfa in 2011 was based upon its relative lack of efficacy rather than safety.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which drotrecogin alfa might cause serum aminotransferase elevations or liver injury is not known. It is a recombinant glycoprotein with the same amino acid sequence as the human protein and thus unlikely to be intrinsically toxic or immunogenic. Allergic reactions and development of antibodies to human protein C were not reported.

Drug Class: Antithrombotic Agents, Agents for Sepsis

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Drotrecogin alfa – Xigris®

DRUG CLASS

Agents for Sepsis

COMPLETE LABELING

Product Withdrawn from Market

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Drotrecogin alfa | 98530-76-8 | Unspecified | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 January 2018

Bernard GR, Vincent JL, Laterre PF, LaRosa SP, Dhainaut JF, Lopez-Rodriguez A, Steingrub JS, et al.; Recombinant human protein C Worldwide Evaluation in Severe Sepsis (PROWESS) study group. Efficacy and safety of recombinant human activated protein C for severe sepsis. N Engl J Med 2001; 344: 699-709. (Among 1690 patients with severe sepsis with organ failure who were treated with drotrecogin alfa or placebo infusions for 96 hours, 28 day all-cause mortality was lower with drotrecogin than placebo [24.7% vs 30.8%]; important side effects included serious bleeding episodes [3.5% vs 2.0%], but "there were no other safety concerns...on the basis of assessments of organ dysfunction, vital signs, serum chemical data, or hematologic data"). 11236773
Bernard GR, Margolis BD, Shanies HM, Ely EW, Wheeler AP, Levy H, Wong K, Wright TJ; Extended Evaluation of Recombinant Human Activated Protein C United States Investigators. Extended evaluation of recombinant human activated protein C United States Trial (ENHANCE US): a single-arm, phase 3B, multicenter study of drotrecogin alfa (activated) in severe sepsis. Chest 2004; 125: 2206-16. (Among 273 adults with severe sepsis with organ failure treated with drotrecogin alfa infusions, the 28 day mortality rate was 26.4% and serious bleeding episodes [the only serious adverse event attributed to drug] occurred in 4%; no mention of serum enzyme elevations or hepatotoxicity). 15189943
Abraham E, Laterre PF, Garg R, Levy H, Talwar D, Trzaskoma BL, François B, et al; Administration of Drotrecogin Alfa (Activated) in Early Stage Severe Sepsis (ADDRESS) Study Group. Drotrecogin alfa (activated) for adults with severe sepsis and a low risk of death. N Engl J Med 2005; 353: 1332-41. (Among 2613 patients with severe sepsis but a "low risk of death" who were treated with drotrecogin alfa or placebo infusions for 96 hours, 28 day mortality was similar in both groups [18.5% vs 17%] while serious bleeding episodes were more frequent with drotrecogin [2.4% vs 1.2%]; no mention or serum enzyme elevations or hepatotoxicity). 16192478
Payen D, Sundin DP, Nelson DR, Williams MD. Analysis of efficacy and safety of drotrecogin alfa (activated) in surgical patients, using an international integrated database. Surgery 2007; 142: 426-7. (Among 1659 patients with severe sepsis following surgery who participated in 5 clinical studies of drotrecogin alfa vs placebo, serious bleeding episodes were more common with drotrecogin than placebo [4.9% vs 0.5%], but were rarely fatal). 17723900
Laterre PF, Abraham E, Janes JM, Trzaskoma BL, Correll NL, Booth FV. ADDRESS (ADministration of DRotrecogin alfa [activated] in Early stage Severe Sepsis) long-term follow-up: one-year safety and efficacy evaluation. Crit Care Med 2007; 35: 1457-63. (Among 2640 patients who received drotrecogin alfa or placebo infusions for an episode of "early stage" severe sepsis with organ failure [Abraham 2005], one year follow up was available on 2376 at which time mortality rates were similar [34.2% vs 34%]). 17452935
Payen D, Sablotzki A, Barie PS, Ramsay G, Lowry S, Williams M, Sarwat S, et al. International integrated database for the evaluation of severe sepsis and drotrecogin alfa (activated) therapy: analysis of efficacy and safety data in a large surgical cohort. Surgery 2007; 141: 548-61. (Retrospective analysis using a large integrated database on patients with severe sepsis after surgery who received drotrecogin alfa found that serious adverse events were more common with drotrecogin than placebo [7.5% vs 6.3%] as were severe bleeding episodes [4.9% vs 0.5%]; no mention of liver related adverse events). 17431957
Nadel S, Goldstein B, Williams MD, Dalton H, Peters M, Macias WL, Abd-Allah SA, et al.; REsearching severe Sepsis and Organ dysfunction in children: a gLobal perspective (RESOLVE) study group. Drotrecogin alfa (activated) in children with severe sepsis: a multicentre phase III randomised controlled trial. Lancet 2007; 369 (9564): 836-43. (Among 477 children with severe sepsis and organ failure treated with infusions of drotrecogin alfa vs placebo for 96 hours, 28 day mortality [17.2% vs 17.5%] and rates of severe bleeding [6.7% vs 6.8%] were similar and "the overall safety profile [was] acceptable"; no mention of serum enzyme elevations or hepatotoxicity). 17350452
Dhainaut JF; INDEPTH Clinical Evaluation Committee. International integrated database for the evaluation of severe sepsis (INDEPTH): clinical evaluation committee report on the safety of drotrecogin alfa (activated) therapy. Curr Med Res Opin 2008; 24: 1187-97. (Among 4459 patients with severe sepsis enrolled in studies of drotrecogin alfa vs placebo and analyzed in an integrated database, total serious adverse event rates were similar [13.2% vs 13.8%], while serious bleeding episodes more frequent with drotrecogin than placebo [5.6% vs 2.0%] and arterial thrombotic events less common with drotrecogin [1.8% vs 2.9%]). 18348744
Woodward B, Cartwright M. Safety of drotrecogin alfa (activated) in severe sepsis: data from adult clinical trials and observational studies. J Crit Care 2009; 24: 595-602. (Review of safety analyses of 2 controlled and 4 open label trials of drotrecogin alfa in severe sepsis from the sponsor focuses upon serious bleeding episodes and does not discuss serum enzyme elevations or hepatotoxicity). 19327331
Poole D, Bertolini G, Garattini S. Errors in the approval process and post-marketing evaluation of drotrecogin alfa (activated) for the treatment of severe sepsis. Lancet Infect Dis 2009; 9: 67-72. (Analysis of the approval of drotrecogin alfa in the US and Europe points out that the approval was based upon analysis of subgroups of patients in the initial single trial in patients with severe sepsis and organ failure). 19095197
Steingrub JS, Cheatham ML, Woodward B, Wang HT, Effron MB; XEUS Investigators. A prospective, observational study of Xigris Use in the United States (XEUS). J Crit Care 2010; 25: 660. (Among 548 adults with severe sepsis treated with drotrecogin alfa in clinical practices, 28 day mortality was 36.7% and the rate of serious bleeding episodes 3.1%; no mention of serum enzyme elevations or hepatotoxicity). 20435433
Kalil AC, LaRosa SP. Effectiveness and safety of drotrecogin alfa (activated) for severe sepsis: a meta-analysis and metaregression. Lancet Infect Dis 2012; 12: 678-86. (Systematic review of literature [9 controlled trials and 20 open label studies] on drotrecogin alfa therapy of severe sepsis concludes that drotrecogin treatment was associated with a reduction in hospital mortality). 22809883
Ranieri VM, Thompson BT, Barie PS, Dhainaut JF, Douglas IS, Finfer S, Gårdlund B, et al; PROWESS-SHOCK Study Group. Drotrecogin alfa (activated) in adults with septic shock. N Engl J Med 2012; 366: 2055-64. (Among 1697 patients with septic shock treated with drotrecogin alfa or placebo infusions for 96 hours, 28 day mortality was similar in both groups [26.4% vs 24.7%], while serious adverse events were more frequent with drotrecogin [14.3% vs 11.5%] as was serious bleeding [8.6% vs 4.8%]; rates of hepatic failure were similar in both groups). 22616830
Holder AL, Huang DT. A dream deferred: the rise and fall of recombinant activated protein C. Crit Care 2013; 17: 309. (Commentary on Ranieri [2012] concludes that "drotrecogin should no longer be recommended in sepsis guidelines as a standard of care"). 23509922
Annane D, Timsit JF, Megarbane B, Martin C, Misset B, Mourvillier B, Siami S, et al.; APROCCHSS Trial Investigators. Recombinant human activated protein C for adults with septic shock: a randomized controlled trial. Am J Respir Crit Care Med 2013; 187: 1091-7. (Among 411 patients with septic shock treated with drotrecogin alfa, corticosteroids, both or placebos, 90 day mortality was the same for the regimens with or without drotrecogin [47.6% vs 46.3%] as were the rates of serious adverse events [53.8% vs 54.7%] and serious bleeding [12,5% vs 14.3%]; no mention of serum enzyme elevations or hepatotoxicity). 23525934
Miranda CJ, Mason JM, Babu BI, Sheen AJ, Eddleston JM, Parker MJ, Pemberton P, Siriwardena AK. Twenty-four hour infusion of human recombinant activated protein C (Xigris) early in severe acute pancreatitis: The XIG-AP 1 trial. Pancreatology 2015; 15: 635-41. (Among 19 patients with severe acute pancreatitis treated with drotrecogin alfa infusions for 24 hours, 28 day mortality was slightly but not significantly higher than that of historical controls [11% vs 5%] and treated patients had no serious bleeding episodes; no mention of serum enzyme elevations or hepatotoxicity). 26547592

## OTHER REFERENCE LINKS

1. Recent References on Drotrecogin alfa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Drotrecogin+alfa/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Drotrecogin alfa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Drotrecogin+alfa)